# Basiliximab

## OVERVIEW

### Introduction

Basiliximab is a chimeric mouse-human monoclonal antibody to CD25, the alpha subunit of the IL-2 receptor, which is found on the surface of T cells. Basiliximab has potent immunosuppressive activity and is used for prevention of organ transplant rejection. Basiliximab has not been linked to serum enzyme elevations during therapy or implicated in cases of clinically apparent liver injury.

### Background

Basiliximab (ba” si lix’ i mab) is a recombinant humanized monoclonal IgG1 kappa antibody to the alpha subunit of the IL2 receptor (CD25). The IL2 receptor is found on T cells and its engagement results in activation of T cells and generation of pro-inflammatory cytokines. Inhibition of the receptor with antibody results in prevention of activation and proliferation of T cells and inhibition of T cell responses. Basiliximab has been shown to decrease the rate of acute cellular rejection after solid organ transplantation and to improve long term graft and patient survival. Basiliximab was approved for use in the United States in 1998 for renal transplantation and continues to be used, typically in induction regimens starting at the time of or shortly before transplantation. It is also used off-label for liver, heart and lung transplantation. Basiliximab has been under evaluation in several autoimmune diseases. Basiliximab is available in powder form in single dose vials of 10 and 20 mg under the brand name Simulect. The recommended regimen of basiliximab is two doses of 20 mg each, each dose given intravenously, the first 2 hours before and the second 4 days after transplantation. The dose in children is 10 mg in the same schedule. Basiliximab should be prescribed only by physicians with experience in immunosuppressive therapy and management of organ transplant patients. Common side effects include infusion reactions, chills, fever, skin rash, fatigue, diarrhea, nausea, headache, anorexia, leukopenia and infections. Rare, but potentially severe side effects include acute hypersensitivity reactions, anaphylaxis, capillary leak syndrome, cytokine release syndrome and progressive multifocal leukoencephalopathy.

### Hepatotoxicity

Because basiliximab is typically given at the time of renal or liver transplantation, its role in causing serum aminotransferase or alkaline phosphatase elevations is usually difficult to define. In general, side effects including liver test abnormalities have been no more frequent after basiliximab therapy as with placebo or comparator treatments. There have been no reports of clinically apparent liver injury attributable to basiliximab infusions. Basiliximab is a monoclonal antibody and is metabolized in the liver, but is unlikely to have intrinsic toxicity.

Basiliximab has potent immunosuppressive activity and might be expected to cause reactivation of chronic hepatitis B. Neither problem has been reported with basiliximab, possibly because patients undergoing solid organ transplantation are usually screened for hepatitis B and routinely given prophylaxis against reactivation. Similarly for chronic hepatitis C, the immunosuppression that is given to prevent transplant rejection can worsen hepatitis C, but basiliximab infusions at the time of transplant do not appear to affect the course of subsequent hepatitis C. In prospective studies, basiliximab based, corticosteroid-free immunosuppressive regimens have not had a clear advantage over standard regimens in ameliorating chronic hepatitis C.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Transplant Agents, Monoclonal Antibodies

Other Drugs in the Subclass, Monoclonal Antibodies: Alemtuzumab, Daclizumab, Muromonab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Basiliximab – Simulect®

DRUG CLASS

Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Basiliximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Basiliximab | 179045-86-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 21 September 2017

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
New monoclonal antibodies to prevent transplant rejection. Med Lett Drugs Ther 1998; 40 (1036): 93-4. (Concise review of the efficacy and safety of basiliximab and daclizumab, two monoclonal antibodies to the IL2 receptor, shortly after their approval for use in transplantation in the US; no mention of ALT elevations or hepatotoxicity for either). 9774964
Nashan B, Moore R, Amlot P, Schmidt AG, Abeywickrama K, Soulillou JP. Randomised trial of basiliximab versus placebo for control of acute cellular rejection in renal allograft recipients. CHIB 201 International Study Group. Lancet 1997; 350 (9086): 1193-8. (Among 380 kidney transplant recipients given basiliximab or placebo on day 0 and 4 after transplant followed by standard immunsuppressive therapy, acute rejection within 6 months was less with basiliximab [30% vs 44%], but the pattern and frequency of side effects were similar and "no clinically relevant differences were found between the two groups in terms of changes in laboratory indices"). 9652559
Marino IR, Doria C, Scott VL, Foglieni CS, Lauro A, Piazza T, Cintorino D, et al. Efficacy and safety of basiliximab with a tacrolimus-based regimen in liver transplant recipients. Transplantation 2004; 78: 886-91. (Among 50 patients undergoing liver transplantation who received basiliximab on days 0 and 4 after transplant, 88% remained rejection-free and the infusions were well tolerated with no immediate side effects). 15385809
Lladó L, Xiol X, Figueras J, Ramos E, Memba R, Serrano T, Torras J, et al.; Thosin Study Group. Immunosuppression without steroids in liver transplantation is safe and reduces infection and metabolic complications: results from a prospective multicenter randomized study. J Hepatol 2006; 44: 710-6. (Among 198 patients undergoing liver transplantation given induction therapy with basiliximab and treated with tacrolimus, rates of acute rejection, recurrent hepatitis C and survival were similar with or without corticosteroids, but new onset hypertension and diabetes were less; no immediate side effects of basiliximab were reported). 16487622
Schmeding M, Sauer IM, Kiessling A, Pratschke J, Neuhaus R, Neuhaus P, Neumann UP. Influence of basiliximab induction therapy on long term outcome after liver transplantation, a prospectively randomised trial. Ann Transplant 2007; 12: 15-21. (Among 99 patients undergoing liver transplantation with or without basiliximab induction, the incidence and severity of rejection and both graft and patient survival were similar; basiliximab had no discernable acute adverse reactions). 18290565
Gras JM, Gerkens S, Beguin C, Janssen M, Smets F, Otte JB, Sokal E, Reding R. Steroid-free, tacrolimus-basiliximab immunosuppression in pediatric liver transplantation: clinical and pharmacoeconomic study in 50 children. Liver Transpl 2008; 14: 469-77. (Among 50 children undergoing liver transplantation who received basiliximab and tacrolimus without corticosteroids, 3 year patient and graft survival were excellent [96% and 94%] and no adverse events attributable to basiliximab were observed). 18383091
Kandus A, Arnol M, Omahen K, Oblak M, Vidan-Jeras B, Kmetec A, Bren AF. Basiliximab versus daclizumab combined with triple immunosuppression in deceased donor renal transplantation: a prospective, randomized study. Transplantation 2010; 89: 1022-7. (Among 212 patients given induction therapy before renal transplantation with either basiliximab or daclizumab, there were no differences in rates of rejection, graft or patient survival or adverse events; no mention of ALT elevations or hepatotoxicity). 20075788
Cai J, Terasaki PI. Induction immunosuppression improves long-term graft and patient outcome in organ transplantation: an analysis of United Network for Organ Sharing registry data. Transplantation 2010; 90: 1511-5. (Since 2003, most solid organ transplant recipients have received induction therapy and analyses of the UNOS registry for this period show highest rates of patient and graft survival with alemtuzumab [89% 5 year patient survival] as compared to antithymocyte globulin [89%], basiliximab [84%], daclizumab [77%], steroids [75%] or no induction [71%]). 21057388
Klintmalm GB, Davis GL, Teperman L, Netto GJ, Washburn K, Rudich SM, Pomfret EA, et al. A randomized, multicenter study comparing steroid-free immunosuppression and standard immunosuppression for liver transplant recipients with chronic hepatitis C. Liver Transpl 2011; 17: 1394-403. (Among 295 patients undergoing liver transplantation for chronic hepatitis C treated with daclizumab, mycophenolate and tacrolimus or a corticosteroid containing regimen without daclizumab, there were no differences between groups in graft or patient survival or in biochemical and histological severity of recurrent hepatitis C). 21850690
Ponticelli C. Basiliximab: efficacy and safety evaluation in kidney transplantation. Expert Opin Drug Saf 2014; 13: 373-81. (Review of efficacy and safety of basiliximab concludes that it "can significantly decrease the risk of acute rejection in kidney transplant recipients without increasing adverse events"). 24266670
Tan Y, Xiao H, Wu D, Luo Y, Lan J, Liu Q, Yu K,et al. Combining therapeutic antibodies using basiliximab and etanercept for severe steroid-refractory acute graft-versus-host disease: A multi-center prospective study. Oncoimmunology. 2017; 6: e1277307. (Among 65 patients with severe, steroid-resistant graft-vs-host disease after hematopoietic cell transplant treated with baxiliximab and etanercept, the complete response rate was 75% and there were no reports of severe hepatic adverse events). 28405499
Melis M, Biagi C, Småbrekke L, Nonino F, Buccellato E, Donati M, Vaccheri A, et al. Drug-induced progressive multifocal leukoencephalopathy: a comprehensive analysis of the WHO adverse drug reaction database. CNS Drugs 2015; 29: 879-91. (Among 1617 reports of PML entered into the WHO VigiBase between 1968 and 2014, commonly associated drugs included rituximab [519], natalizumab [618], rituximab [519], methotrexate [244] and cyclophosphamide [215], but also alemtuzumab [38], ATG [11] and basilixumab [4]). 26507833

## OTHER REFERENCE LINKS

1. Recent References on Basiliximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Basiliximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Basiliximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Basiliximab)